# Seladelpar

## OVERVIEW

### Introduction

Seladelpar is an orally available peroxisome proliferator-activated receptor delta (PPARδ) agonist that is used in combination with ursodeoxycholic acid to treat primary biliary cholangitis (PBC). Seladelpar therapy is associated with rare instances of worsening of liver enzymes during therapy but has not been convincingly linked to episodes of clinically apparent liver injury with jaundice.

### Background

Seladelpar (sel’ a del’ par) is an agonist of the peroxisome proliferator-activated receptor delta (PPARδ) that is approved for use in primary biliary cholangitis (PBC). The PPARs (α, β, and δ) are intracellular receptors that have major effects on bile acid synthesis and transport as well as lipid metabolism and glucose homeostasis. Studies of other PPAR agonists such as pioglitazone and fenofibrate have suggested at least partial improvement in disease activity with their use in several liver diseases. Furthermore, the PPARα agonist bezafibrate has been shown to improve liver tests and histology in patients with PBC and is approved for this use in Europe and Japan. PBC is a chronic liver disease that occurs most commonly in middle aged women and is characterized by gradual inflammatory destruction of small bile ducts that slowly leads to cirrhosis and end-stage liver disease. The first line approved therapy of PBC is use of ursodeoxycholic acid (ursodiol), a hydrophilic bile acid, which has been shown to improve liver tests results and slow progression of disease. Seladelpar also has now been shown to improve serum enzymes and symptoms in patients with PBC. In a large, placebo-controlled trial in patients with PBC and an incomplete response to ursodiol, seladelpar therapy was associated with significant improvements in serum alkaline phosphatase levels in 62% of treated patients compared to only 20% of placebo recipients. Furthermore, alkaline phosphatase levels became normal in 25% receiving seladelpar vs none on placebo. Treatment was also associated with improvements in symptoms of pruritus and in serum lipids. Based upon its effects on alkaline phosphatase levels, seladelpar was granted accelerated approval in 2024 for treatment of adults with PBC who have an inadequate response to or intolerance of ursodiol. Seladelpar is typically given in combination with ursodiol but can be given as monotherapy in those with intolerance to ursodiol. Seladelpar has not been shown to prolong survival or prevent progression to cirrhosis in patients with PBC, and its continued approval is contingent on further demonstration of its clinical benefit. Seladelpar is available as capsules of 10 mg under the brand name Livdelzi. The recommended dose is 10 mg once daily. Seladelpar is not recommended for patients with advanced or decompensated cirrhosis, or complete biliary obstruction. Common adverse events include headache, abdominal pain and distension, nausea, indigestion, rash, and dizziness. Uncommon but potentially severe adverse events include bone fractures and hypersensitivity reactions. Seladelpar has not been evaluated in pregnancy, and women of childbearing potential should be tested for pregnancy before starting seladelpar and practice an effective means of birth control during therapy.

### Hepatotoxicity

In preregistration clinical trials, seladelpar was found to decrease both serum aminotransferase and alkaline phosphatase elevations in a high proportion of patients with PBC. However, in preliminary dose-finding studies in patients with PBC, transient elevations of ALT and AST levels above 5 times the upper limit of normal (ULN) occurred in 3 of 25 subjects exposed to doses of 50 and 200 mg daily but in no placebo-treated patients. The elevations occurred during the few months of therapy and resolved rapidly upon drug discontinuation. Interestingly, alkaline phosphatase levels decreased markedly during the ALT elevations and rose to pretreatment levels soon after discontinuation.

In contrast, in subsequent clinical trials of seladelpar in doses of 10 mg daily in patients with PBC, ALT elevations above 5 times ULN were rare, occurred randomly, and were usually attributable to other causes. In the major preregistration randomized placebo-controlled trial, drug discontinuations because of liver test abnormalities arose in 2 of 128 patients [1.6%] receiving seladelpar vs 2 of 65 [3.1%] on placebo. In multiple small clinical trials, there were no episodes of clinically apparent liver injury that were considered due to seladelpar. However, the total clinical experience with seladelpar has been limited, and rare instances of drug induced liver injury are known to occur with other PPAR agonists, such as fenofibrate, bezafibrate, pioglitazone and rosiglitazone. In long term extension studies, decompensation and jaundice arose in a small number of patients taking seladelpar, but in all instances these outcomes arose in patients with preexisting cirrhosis and were interpreted as due to disease progression independent of therapy. Nevertheless, seladelpar and other PPAR agonists are not recommended for patients with advanced or decompensated cirrhosis, and routine monitoring of liver tests is recommended during therapy.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which seladelpar might cause liver injury is unclear, but clinically apparent liver injury from other fibrates and PPAR agonists is likely immune mediated. Seladelpar is metabolized in the liver by multiple CYP isoenzymes and is susceptible to drug-drug interactions with strong inhibitors or inducers of CYP2C9.

### Outcome and Management

The product label for seladelpar has a warning about drug induced liver injury and recommends assessing symptoms, signs, and laboratory features of liver disease before starting therapy and monitoring thereafter, with interruption if liver tests worsen or signs and symptoms of acute liver injury arise. If liver tests improve upon stopping but recur with restarting seladelpar, therapy should be permanently discontinued. There is little or no information on cross sensitivity to liver injury or adverse events between seladelpar and other therapies for PBC such as ursodiol, obeticholic acid, elafibranor, and fenofibrate.

Drug Class: Liver Disease Agents; Obeticholic Acid, Ursodiol

Other PPAR Agonists: Bezafibrate, Elafibranor, Fenofibrate, Pioglitazone, Rosiglitazone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Seladelpar – Livdelzi®

DRUG CLASS

Liver Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Seladelpar)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Seladelpar | 851528-79-5 | C21-H23-F3-O5-S
Elafibranor | 923978-27-2 | C22-H24-O4-S
Bezafibrate | 41859-67-0 | C19-H20-ClNO4
Fenofibrate | 49562-28-9 | C20-H21-ClO4

## ANNOTATED SELECTED BIBLIOGRAPHY

References updated: 18 September 2024

Abbreviations: PBC, primary biliary cholangitis (cirrhosis); PPAR, peroxisome proliferator-activated receptor; PSC, primary sclerosing cholangitis.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of PPAR agonists).
Powers AC, D’Alessio D. Thiazolidinediones: Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Halal R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 876-7. (Textbook of pharmacology and therapeutics, discusses PPAR-gamma agonists only).
FDA. Integrated Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217899Orig1s000IntegratedR.pdf (FDA website with product label and integrated clinical review of data on seladelpar provided by the sponsor in support of its approval as therapy of primary biliary cholangitis [PBC], mentions that serum aminotransferase elevations occurred with high doses of seladelpar (50 and 200 mg daily) but were not observed with the currently recommended dosage (10 mg daily); nevertheless, instances of hepatic decompensation did occur in some patients with advanced cirrhosis treated with seladelpar and warnings were recommended for monitoring patients for liver test abnormalities before and during treatment, and not using seladelpar in patients with decompensated cirrhosis or complete biliary obstruction).
Iwasaki S, Ohira H, Nishiguchi S, Zeniya M, Kaneko S, Onji M, Ishibashi H, et al.; Study Group of Intractable Liver Diseases for Research on a Specific Disease, Health Science Research Grant, Ministry of Health, Labour and Welfare of Japan. The efficacy of ursodeoxycholic acid and bezafibrate combination therapy for primary biliary cirrhosis: A prospective, multicenter study. Hepatol Res. 2008;38:557-64. (Study one: Among 45 patients with PBC treated with either bezafibrate or ursodiol, serum Alk P levels improved similarly in both groups and were within normal limits in 58% vs 38% by 24 weeks. Study two: Among 21 patients with PBC with an incomplete response to ursodiol, addition of bezafibrate led to further improvements in Alk P levels that were within normal limits in 60% by week 24 but remained elevated in all who did not have bezafibrate added; no mention of worsening liver tests, but 3 of 31 bezafibrate treated subjects developed CPK elevations). 18452482
Levy C, Peter JA, Nelson DR, Keach J, Petz J, Cabrera R, Clark V, et al. Pilot study: fenofibrate for patients with primary biliary cirrhosis and an incomplete response to ursodeoxycholic acid. Aliment Pharmacol Ther. 2011;33:235-42. (Among 20 patients with an incomplete response to ursodiol treated with addition of fenofibrate [160 mg/day] for 48 weeks, Alk P levels decreased [median 351 to 171 U/L] as did AST and IgM levels, while pruritus rates did not change and adverse events included heartburn [25%] and transient, early 2- to 5-fold increases in ALT and AST [10%] but no clinically apparent liver injury with jaundice). 21083674
Ratziu V, Harrison SA, Francque S, Bedossa P, Lehert P, Serfaty L, Romero-Gomez M, et al.; GOLDEN-505 Investigator Study Group. Elafibranor, an agonist of the peroxisome proliferator-activated receptor-α and -δ, induces resolution of nonalcoholic steatohepatitis without fibrosis worsening. Gastroenterology. 2016;150:1147-1159.e5. (Among 276 patients with nonalcoholic steatohepatitis [NASH] without cirrhosis treated with elafibranor [80 and 120 mg] or placebo once daily for 52 weeks, there were no differences in rates of NASH resolution in the 3 groups although serum alkaline phosphatase and GGT levels decreased more on elafibranor; while rates of adverse events were similar in the 3 groups, those on elafibranor were more likely to have nausea, vomiting, diarrhea, renal impairment, myalgia, decreased appetite, and rash; no mention of worsening of ALT or hepatotoxicity). 26874076
Cheung AC, Lapointe-Shaw L, Kowgier M, Meza-Cardona J, Hirschfield GM, Janssen HL, Feld JJ. Combined ursodeoxycholic acid (UDCA) and fenofibrate in primary biliary cholangitis patients with incomplete UDCA response may improve outcomes. Aliment Pharmacol Ther. 2016;43:283-93. (In a retrospective analysis, comparison of patients with PBC treated with ursodiol alone [n=66] or combined with fenofibrate [n=66: cohorts matched for age, cirrhosis, Alk P, bilirubin and platelet counts] for a median of 11 months demonstrated greater decreases in Alk P levels and improved decompensation- and transplant-free survival with fenofibrate, but 1 patient developed ALT elevations above 5 times ULN after 5.4 years which resolved upon stopping). 26559762
Hegade VS, Khanna A, Walker LJ, Wong LL, Dyson JK, Jones DEJ. Long-term fenofibrate treatment in primary biliary cholangitis improves biochemistry but not the UK-PBC risk score. Dig Dis Sci. 2016;61:3037-3044. (Among 23 patients with PBC and an incomplete response to ursodiol who were treated with the addition of fenofibrate [200 mg daily] for a median of 21 months, there were sustained improvements in Alk P levels, but no improvement in the UK-PBC risk scores for decreasing liver related deaths or liver transplantations). 27435324
Jones D, Boudes PF, Swain MG, Bowlus CL, Galambos MR, Bacon BR, Doerffel Y, et al. Seladelpar (MBX-8025), a selective PPAR-δ agonist, in patients with primary biliary cholangitis with an inadequate response to ursodeoxycholic acid: a double-blind, randomised, placebo-controlled, phase 2, proof-of-concept study. Lancet Gastroenterol Hepatol. 2017;2:716-726. (Among 41 patients with PBC and an incomplete response to ursodiol treated with seladelpar [50 or 200 mg] or placebo daily, 3 treated patients developed marked elevations in serum ALT and AST without symptoms or jaundice within the first few weeks that reversed rapidly with discontinuation and that also led to the early termination of the trial, nevertheless by 12 weeks mean Alk P levels had decreased by 53% in seladelpar- vs only 2% in placebo-recipients). 28818518
Reig A, Sesé P, Parés A. Effects of bezafibrate on outcome and pruritus in primary biliary cholangitis with suboptimal ursodeoxycholic acid response. Am J Gastroenterol. 2018;113:49-55. (Among 48 patients with PBC with an incomplete response to ursodiol who had the addition of bezafibrate, alkaline phosphatase fell into the normal range in 26 [54%] who also had improvements in itching and subsequently suffered no serious clinical outcomes [liver decompensation, cancer, death or liver transplantation], while the 22 not achieving normal alkaline phosphatase levels had less improvement in itching and 5 instances of serious clinical outcomes). 29016567
Corpechot C, Chazouillères O, Rousseau A, Le Gruyer A, Habersetzer F, Mathurin P, Goria O, et al. A placebo-controlled trial of bezafibrate in primary biliary cholangitis. N Engl J Med. 2018;378:2171-2181. (Among 100 patients with PBC and an incomplete response to ursodiol treated with bezafibrate or placebo for 24 months, Alk P levels fell into the normal range in 67% vs 2% and symptoms improved slightly, while adverse event rates were similar [49% vs 51%], including serious adverse events [28% vs 24%] and ALT elevations rising to 5 times ULN occurred in 6% vs 2%; 2 patients on bezafibrate having liver biopsy appearance of autoimmune hepatitis discontinued therapy and were treated successfully with corticosteroids). 29874528
Honda A, Tanaka A, Kaneko T, Komori A, Abe M, Inao M, Namisaki T, et al.; Japan PBC Study Group. Bezafibrate improves GLOBE and UK-PBC scores and long-term outcomes in patients with primary biliary cholangitis. Hepatology. 2019;70:2035-2046. (Among 118 Japanese patients with PBC treated with ursodiol for at least a year followed by its combination with bezafibrate for a year, there was no decrease in risk of clinical outcomes but there were changes in risk scores that predicted fewer outcome in the future). 30737815
Lleo A, Wang GQ, Gershwin ME, Hirschfield GM. Primary biliary cholangitis. Lancet. 2020;396(10266):1915-1926. (Review of the clinical features, diagnosis, natural history, etiology, and therapy of PBC; no mention of hepatoxicity of medications used in treatment). 33308474
Ghonem NS, Auclair AM, Hemme CL, Gallucci GM, de la Rosa Rodriguez R, Boyer JL, Assis DN. Fenofibrate improves liver function and reduces the toxicity of the bile acid pool in patients with primary biliary cholangitis and primary sclerosing cholangitis who are partial responders to ursodiol. Clin Pharmacol Ther. 2020;108:1213-1223. (In a retrospective analysis of 31 patients with PBC or PSC with an incomplete response to ursodiol therapy who had the addition of fenofibrate [160 mg daily], alkaline phosphatase levels fell into the normal range in 84% and total serum bile acid levels improved as well). 32480421
de Vries E, Bolier R, Goet J, Parés A, Verbeek J, de Vree M, Drenth J, et al.; Netherlands Association for the Study of the Liver-Cholestasis Working Group. Fibrates for itch (FITCH) in fibrosing cholangiopathies: a double-blind, randomized, placebo-controlled trial. Gastroenterology. 2021;160:734-743.e6. (Among 74 patients with moderate-to-severe pruritus due to chronic cholestatic liver disease treated with bezafibrate or placebo for 21 days, serum alkaline phosphatase levels and pruritus decreased with bezafibrate but not placebo and there were no serious adverse events or episodes of worsening of serum liver enzymes). 33031833
Sorda JA, González Ballerga E, Barreyro FJ, Avagnina A, Carballo P, Paes de Lima A, et al. Bezafibrate therapy in primary biliary cholangitis refractory to ursodeoxycholic acid: a longitudinal study of paired liver biopsies at 5 years of follow up. Aliment Pharmacol Ther. 2021;54:1202-1212. (Among 49 patients with PBC and an incomplete response to ursodiol who were treated with addition of bezafibrate, serum Alk P levels fell into the normal range in 86% by 1 year and repeat liver biopsies in 31 patients at 5 years showed a decrease in fibrosis in 48% and decline in cirrhosis rate from 19% to 3%). 34587309
Schattenberg JM, Pares A, Kowdley KV, Heneghan MA, Caldwell S, Pratt D, Bonder A, et al. A randomized placebo- controlled trial of elafibranor in patients with primary biliary cholangitis and incomplete response to UDCA. J Hepatol. 2021;74:1344-1354. (Among 45 patients with PBC and an incomplete response to ursodiol treated with elafibranor [80 or 120 mg] or placebo once daily for 12 weeks, serum levels of alkaline phosphatase and GGT decreased with elafibranor but not placebo therapy, while there was little change in symptoms or ALT levels and adverse event rates were similar in all 3 groups although 2 patients receiving elafibranor developed elevations in ALT, both of whom stopped therapy, one received corticosteroids). 33484775
Bowlus CL, Galambos MR, Aspinall RJ, Hirschfield GM, Jones DEJ, Dörffel Y, Gordon SC, et al. A phase II, randomized, open-label, 52-week study of seladelpar in patients with primary biliary cholangitis. J Hepatol. 2022;77:353-364. (Among 119 patients with PBC and an incomplete response to ursodiol treated with seladelpar [2, 5, or 10 mg daily] for 52 weeks, there were dose related decreases in mean Alk P levels by 23% to 43% by 12 weeks and normalization of levels at 52 weeks with the 10 mg dose, while adverse events were generally mild, and although 3 patients developed episodes of ALT elevations, all 3 occurred after starting other drugs [rifampin or ibuprofen]). 35367282
Colapietro F, Gershwin ME, Lleo A. PPAR agonists for the treatment of primary biliary cholangitis: Old and new tales. J Transl Autoimmun. 2023;6:100188. (Review of the clinical experience with use of PPAR agonists as therapy of PBC including beneficial results using bezafibrate, fenofibrate, seladelpar, and elafibranor mentions a single patient who discontinued seladelpar early because of serum ALT elevations above 3 times ULN). 36684809
Kamata S, Honda A, Ishikawa R, Akahane M, Fujita A, Kaneko C, Miyawaki S, et al. Functional and structural insights into the human PPARα/δ/γ targeting preferences of anti-NASH investigational drugs, lanifibranor, seladelpar, and elafibranor. Antioxidants (Basel). 2023;12:1523. (Functional assays for PPARα, δ, and γ binding and activity demonstrate that elafibranor binds to and activates all three subtypes of PPAR, inducing antioxidant genes, as well as mediators of pathways of lipid and glucose metabolism and inflammation). 37627519
Jorge Nardelli M, Rodrigues Maffia L, Alves Gelape F, Grossi Lopes Cançado G, Alves Couto C. Bezafibrate severe late onset drug-induced liver injury in primary biliary cholangitis: case report. J Gastrointestin Liver Dis. 2023;32:413-414. (65 year old woman developed AMA negative PBC with little response to ursodiol and a transient partial response to bezafibrate, eventually with progressive jaundice and death from liver failure interpreted as drug induced liver injury but with latency of several years, no dechallenge on stopping, and course compatible with progressive PBC and lack of sustained response to bezafibrate). 37774223
Liu Y, Guo G, Zheng L, Sun R, Wang X, Deng J, Jia G, et al. Effectiveness of fenofibrate in treatment-naive patients with primary biliary cholangitis: a randomized clinical trial. Am J Gastroenterol. 2023;118:1973-1979. (Among 117 Chinese patients with newly diagnosed PBC treated with ursodiol alone vs ursodiol and fenofibrate [200 mg daily] for 12 months, Alk P fell into the normal range in 40% vs 62% by 12 months, while ALT elevations arose in 8% vs 19%, none were above 5 times ULN and all resolved spontaneously). 36892506
Tanaka A, Corpechot C. PPAR agonists in PBC: where do we go from here? Or how to choose between the new and the old. Clin Res Hepatol Gastroenterol. 2024;48:102358. (Review of recent phase 3 trials of seladelpar and elafibranor [PPAR agonists] demonstrating achievement of endpoint of improvements in serum alkaline phosphatase but not a decrease in long term complications of PBC, whereas the many trials of bezafibrate with long term follow up have shown improvements in alkaline phosphatase levels and also liver histology, fibrosis, and in mortality and need for liver transplantation). 38677506
Mayo MJ, Vierling JM, Bowlus CL, Levy C, Hirschfield GM, Neff GW, Galambos MR, et al. Open-label, clinical trial extension: Two-year safety and efficacy results of seladelpar in patients with primary biliary cholangitis. Aliment Pharmacol Ther. 2024;59:186-200. (Among 106 patients with PBC and an incomplete response to ursodiol who participated in early phase trials of seladelpar and were then enrolled in open-label extension studies, liver tests continued to improve over 2 years and there were no liver-related serious adverse events). 37904314
Hirschfield GM, Bowlus CL, Mayo MJ, Kremer AE, Vierling JM, Kowdley KV, Levy C, et al.; RESPONSE Study Group. A phase 3 trial of seladelpar in primary biliary cholangitis. N Engl J Med. 2024;390:783-794. (Among 193 patients with PBC and an incomplete response or intolerance to ursodiol treated with addition of seladelpar [10 mg] or placebo once daily for 12 months, Alk P levels improved more with seladelpar [-42% vs -4.3% from baseline] and fell into the normal range in 25% [vs none] with accompanying improvements in pruritus, while total and severe adverse event rates were similar and there were no treatment-related serious hepatic adverse events). 38381664
Kowdley KV, Bowlus CL, Levy C, Akarca US, Alvares-da-Silva MR, Andreone P, Arrese M, et al.; ELATIVE Study Investigators’ Group; ELATIVE Study Investigators' Group. Efficacy and safety of elafibranor in primary biliary cholangitis. N Engl J Med. 2024;390:795-805. (Among 161 patients with PBC and an incomplete response to ursodiol treated with elafibranor [80 mg] or placebo for 52 weeks, improvements in alkaline phosphatase to less than 167 U/L occurred in 51% of those on elafibranor vs 4% on placebo, and while total [96% vs 91%] and serious adverse event rates [11% vs 11%] were similar in the 2 groups, those on elafibranor were more likely to have abdominal pain [11% vs 6%], diarrhea [11% vs 9%], nausea [11% vs 6%] and vomiting [11% vs 2%], and 1 patient on elafibranor developed possible and 2 on placebo developed probable drug induced liver injury). 37962077

## OTHER REFERENCE LINKS

1. Recent References on Seladelpar: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Seladelpar/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Seladelpar: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Seladelpar)